# Terazosin

## OVERVIEW

### Introduction

Terazosin is a nonselective alpha-1 adrenergic antagonist used in the therapy of hypertension and benign prostatic hypertrophy. Terazosin therapy is associated with a low rate of transient serum aminotransferase elevations and to rare instances of clinically apparent acute liver injury.

### Background

Terazosin (ter ay' zoe sin) was the second alpha-1 adrenergic antagonist to be approved for use in the United States and is still widely used for therapy of hypertension and benign prostatic hypertrophy. Terazosin inhibits alpha-adrenergic receptors present on smooth muscle in arterioles (so-called alpha-1b adrenergic receptors) as well as in those in the bladder neck and prostate (alpha-1a adrenergic receptors). The inhibition of alpha-adrenergic tone in blood vessels causes relaxation of arteriolar resistance and lowering of the blood pressure. Terazosin was approved for use in the United States in 1987 and is still used for treatment of hypertension, although rarely as a first line agent and usually in combination with other antihypertensive drugs. Terazosin is also approved for alleviation of the symptoms of urinary obstruction due to benign prostatic hypertrophy. More than 4 million prescriptions for terazosin are filled yearly. Terazosin is available in tablets or capsules of 1, 2, 5 and 10 mg generically and under the trade name Hytrin. Terazosin is usually started at a dose of 1 mg daily at bedtime with increase in the dose based upon tolerance and clinical response to an average of 5 to 10 mg daily in one dose daily, usually at bedtime. Side effects include dizziness and syncope (particularly with the initial dose), fatigue, headache, palpitations, impotence, incontinence and gastrointestinal upset. Rare, but potentially severe adverse events include postural hypotension and priapism.

### Hepatotoxicity

Terazosin has been associated with a low rate of serum aminotransferase elevations that in controlled trials was no higher than with placebo therapy. These elevations were transient and did not require dose modification. Instances of serum enzyme elevations, but no instances of clinically apparent acute liver injury with jaundice due to terazosin, have been published. Furthermore, product labels do not include discussion of hepatic toxicity. Cholestatic hepatitis and jaundice have been reported with other alpha-adrenergic blockers. Thus, acute symptomatic liver injury due to terazosin must be exceedingly rare if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the minor serum aminotransferase elevations associated with terazosin is not known. Terazosin is extensively metabolized by the liver and generation of a mildly toxic intermediate is a possible explanation.

References on the safety and potential hepatotoxicity of terazosin and other alpha-blockers are given in the Overview on Alpha-1 Adrenergic Receptor Antagonists.

Drug Class: Antihypertensive Agents, Benign Prostatic Hypertrophy Agents

Other Drugs in the Subclass, Alpha-1 Adrenergic Receptor Antagonists: Doxazosin, Prazosin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Terazosin – Generic, Hytrin®

DRUG CLASS

Antihypertensive Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=terazosin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Terazosin | 63590-64-7 | C19-H25-N5-O4 | Terazosin Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Terazosin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Terazosin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Terazosin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Terazosin)